# Antihistamines

## OVERVIEW

Histamine is an important mediator of immediate hypersensitivity reactions acting locally and causing smooth muscle contraction, vasodilation, increased vascular permeability, edema and inflammation. Histamine acts through specific cellular receptors which have been categorized into four types, H1 through H4. Antihistamines represent a class of medications that block the histamine type 1 (H1) receptors. Importantly, antihistamines do not block or decrease the release of histamine, but rather ameliorate its local actions. Agents that specially block other H2 receptors are generally referred to as H2 blockers rather than antihistamines.

H1 receptors are widely distributed and are particularly common on smooth muscle of the bronchi, gastrointestinal tract, uterus and large blood vessels. H1 receptors are also found in the central nervous system. The antihistamines are widely used to treat symptoms of allergic conditions including itching, nasal stuffiness, runny nose, teary eyes, urticaria, dizziness, nausea and cough. Their most common use alone or in combination with other agents is for symptoms of upper respiratory illnesses such as the common cold. The central nervous system effects of antihistamines include sedation and decrease in anxiety, tension and adventitious movements.

Antihistamines are typically separated into sedating (first generation) and nonsedating (second generation) forms, based upon their central nervous system effects, the nonsedating agents being less likely to cross the blood-brain barrier. In addition, some antihistamines have additional anticholinergic, antimuscarinic or other actions. The antihistamines are some of the most commonly used drugs in medicine, and most are available in multiple forms, both by prescription and in over-the-counter products, alone or combined with analgesics or sympathomimetic agents. Common uses include short term treatment of symptoms of the common cold, seasonal allergic rhinitis (hay fever), motion sickness, nausea, vertigo, cough, urticaria, pruritus and anaphylaxis. The sedating antihistamines are also used as mild sleeping aids and to alleviate tension and anxiety. Many antihistamines are also available in topical forms, as creams, nasal sprays and eye drops for local use in alleviating allergic symptoms. The nonsedating antihistamines are typically used in extended or long term treatment of allergic disorders, including allergic rhinitis (hay fever), sinusitis, atopic dermatitis, and chronic urticaria.

The antihistamines have several adverse side effects which are related to their antihistaminic actions. Side effects are, however, usually mild and rapidly reversed with stopping therapy or decreasing the dose. These common side effects include sedation, impaired motor function, dizziness, dry mouth and throat, blurred vision, urinary retention and constipation. Antihistamines can worsen urinary retention and narrow angle glaucoma.

The antihistamines rarely cause liver injury. Their relative safety probably relates to their use in low doses for a short time only. The nonsedating antihistamines, however, are often used for an extended period and several forms have been linked to rare instances of clinically apparent acute liver injury which has generally been mild and self-limiting; the antihistamines most commonly linked to liver injury have been cyproheptadine, cetirizine and terfenadine (which is no longer in clinical use).

The first generation oral antihistamines in clinical use (with common brand name(s) and year of approval in the United States, if available) include brompheniramine (Bromphen, Dimetapp), chlorpheniramine (Chlor-Timeton: 1971), carbinoxamine (Palgic), clemastine (Tavist: 1977), cyclizine (Marezine, Bonine: 1966), cyproheptadine (Periactin: 1961), diphenhydramine (Benadryl: 1946), dimenhydrinate (Dramamine), doxylamine (Unisom: 1948), hydroxyzine (Atarax, Vistaril: 1957), meclizine (Antivert: 1957), phenyltoloxamine (Acuflex), promethazine (Phenergan: 1957), and triprolidine (Triafed). Second generation antihistamines in general use and used orally include acrivastine (Semprex-D), cetirizine (Zyrtec: 1995), levocetirizine (Xyzal: 2007), loratadine (Claritin: 1993), desloratadine (Clarinex: 2001), and fexofenadine (Allegra: 1996). Links to descriptions of the different antihistamines are given below. References on the safety and hepatotoxicity of the various antihistamines are provided together at the end of this overview section.

First Generation Antihistamines

- Brompheniramine
- Carbinoxamine
- Chlorcyclizine
- Chlorpheniramine
- Clemastine
- Cyclizine
- Cyproheptadine
- Dexbrompheniramine
- Dexchlorpheniramine
- Dimenhydrinate
- Diphenhydramine
- Doxylamine
- Hydroxyzine
- Meclizine
- Phenyltoloxamine
- Promethazine
- Triprolidine

Second Generation Antihistamines

- Acrivastine
- Cetirizine
- Fexofenadine
- Levocetirizine
- Loratadine
- Desloratadine

## ANNOTATED BIBLIOGRAPHY

References updated: 16 January 2017

Zimmerman HJ. H1 Receptor antagonists. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 717-8. (Single author review of hepatotoxicity published in 1999; mentions that only isolated instances of clinically apparent liver injury have been attributed to antihistamines and none to promethazine; antihistamines with more than a single case report of liver injury include cyproheptadine and terfenadine).
Bjørneboe M, Iversen O, Olsen S. Infective hepatitis and toxic jaundice in a municipal hospital during a five year period. Acta Med Scand 1967; 182: 491-501. (Between 1960-64, 620 cases of jaundice [among 23,600 admissions] were seen at 2 hospitals in Copenhagen, 15 being attributed to drug jaundice and one of which was linked to pyribenzamine, a first generation antihistamine). 6054829
Karkalas Y, Lal H. Jaundice following therapy with imipramine and cyproheptadine. Clin Toxicol 1971; 4: 47-53. (59 year old man developed jaundice 5 weeks after starting cyproheptadine and 4 weeks after starting imipramine [bilirubin 3.0 mg/dL, ALT 1110 U/L, Alk P 16.9 KA units], resolving within 3 weeks of stopping both). 5097484
Kew MC, Segel J, Zoutendyk A. Hypersensitivity hepatitis associated with administration of cyclizine. Br Med J 1973; 2: 307. (8 year old girl developed jaundice 8 days after starting a 5 day course of cyclizine [bilirubin 5.5 mg/dL, ALT 460 U/L, Alk P 45 KA units], with recurrence after a single dose [bilirubin 5.2 mg/dL, ALT 400 U/L, Alk P 37 KA units]). 4704507
Henry DA, Low JM, Donnelly T. Jaundice during cyproheptadine treatment. Br Med J 1978; 1: 753. (25 year old woman developed jaundice 1 month after starting cyproheptadine [bilirubin 6.5 mg/dL, ALT 210 U/L, Alk P 2400 U/L], with slow recovery, later tolerating chlorpheniramine). 630623
Hunderi OH. [Intoxication with promethazine as a cause to liver damage]. Tidsskr Nor Laegeforen 1981; 101: 1650-2. Norwegian. (55 year old man took 60 tablets of promethazine and was admitted in coma with subsequent jaundice [bilirubin 20.6 mg/dL, ALT 3000 U/L, Alk P 450 U/L], resolving rapidly and likely due to ischemic hepatitis). 7339949
Simpson GK, Davidson NM. Possible hepatotoxicity of zimelidine. Br Med J (Clin Res Ed) 1983; 287: 1181. (47 year old woman developed jaundice and fever 9 days after starting zimelidine [a derivative of brompheniramine and the first SSRI] for depression [bilirubin 4.2 mg/dL, ALT 300 U/L, Alk P 176 U/L], resolving within 6 weeks of stopping). 6226335
Larrey D, Palazzo L, Benhamou JP. Terfenadine and hepatitis. Ann Intern Med 1985; 103: 634. (43 year old woman developed jaundice 5 months after starting terfenadine [bilirubin 9.2 mg/dL, ALT 920 U/L, Alk P 188 U/L, eosinophils 3%], resolving in 4 months and recurring after two subsequent reexposures). 2864011
Larrey D, Geneve J, Pessayre D, Machayekhi JP, Degott C, Benhamou JP. Prolonged cholestasis after cyproheptadine-induced acute hepatitis. J Clin Gastroenterol 1987; 9: 102-4. (23 year old woman developed abdominal pain 5 days and jaundice 10 days after starting cyproheptadine [initial bilirubin 3.6 mg/dL, ALT 320 U/L, Alk P 250 U/L, GGT 160 U/L], with clinical resolution on stopping, but persistence of Alk P and GGT elevations and liver biopsies showing fibrosis and paucity of bile ducts 1 and 3 years later). 3559100
Pagani A, Rizzetto M. Clofeniramine hepatotoxicity. Ital J Gastroenterol 1987; 19: 179. Not in PubMed (Cited by Zimmerman [1999] as reporting a case of jaundice caused by chlorpheniramine; possibly an abstract).
Freneaux E, Larrey D, Berson A, Pessayre D, Benhamou JP. [Hepatitis caused by cyproheptadine(Periactine). A case and review of the literature]. Gastroenterol Clin Biol 1988; 12: 573-5. French. (23 year old woman developed nausea and fatigue one month after starting cyproheptadine [bilirubin normal, ALT 6.5 times ULN, Alk P 1.3 times ULN], resolving within 3 months of stopping). 3046986
Arendt C, Bernheim J. Double-blind comparison of maintenance treatment of chronic idiopathic urticaria by cetirizine and terfenadine. Curr Ther Res 1989; 46: 724. Not in PubMed (Controlled trial of a 9 week course of cetirizine versus terfenadine in 52 patients with chronic urticaria reported that one patient on terfenadine developed abnormal ALT levels [13 rising to 55 U/L] without symptoms or jaundice during therapy, 4 others had isolated AST elevations [50 to 126 U/L], few other details given).
Moss SF, Walters JR, Tonge KA, Walker JR. Cholestasis associated with cinnarizine. Br Med J 1990; 301: 1281. (70 year old man developed jaundice and itching 3 weeks after starting cinnarizine [a first generation antihistamine] for dizziness [bilirubin 6.8 mg/dL, AST 71 U/L, Alk P 281 U/L], biopsy showing cholestasis, resolving within 3 months of stopping). 2271847
Campoli-Richards DM, Buckley MM, Fitton A. Cetirizine. A review of its pharmacological properties and clinical potential in allergic rhinitis, pollen-induced asthma, and chronic urticaria. Drugs 1990; 40: 762-81. (Review of pharmacology, efficacy and safety of cetirizine, no mention of hepatotoxicity: "In those clinical trials which have performed routine laboratory tests, no clinically significant changes have been reported"). 1981354
Brogden RN, McTavish D. Acrivastine. A review of its pharmacological properties and therapeutic efficacy in allergic rhinitis, urticaria and related disorders. Drugs 1991; 41: 927-40. (Review of pharmacology, efficacy and safety of acrivastine, a second generation antihistamine; among 2600 patients, rates of adverse events were similar in those on acrivastine as on placebo but ALT elevations and hepatotoxicity were not mentioned). 1715267
Bera F, Siproudhis JP, Jonville-Bera AP, Martin MP, Autret E. [Cytolytic hepatic involvement after administration of cetirizine(Zyrtec)]. Gastroenterol Clin Biol 1993; 17: 770-1. French. (46 year old man developed jaundice several months after starting cetirizine for allergic rhinitis [bilirubin 5.4 mg/dL, ALT 217 U/L, Alk P 481 U/L, GGT 445 U/L, eosinophils 4%], resolving within 1 month of stopping, recurring within 10 days of restarting). 8288094
Sahai A, Villeneuve JP. Terfenadine-induced cholestatic hepatitis. Lancet 1996; 348: 552-3. (Two cases: 36 year old man developed jaundice 4 weeks after starting terfenadine [bilirubin 8.9 mg/dL, ALT 556 U/L, Alk P 275 U/L], resolving within 6 months of stopping. 19 year old man developed jaundice 4 weeks after starting terfenadine [bilirubin 10.8 mg/dL, ALT 665 U/L, Alk P 146 U/L], resolving within 3 months). 8757175
Najarian JS. Hepatic necrosis. N J Med 1996; 93: 15. (46 year old woman developed jaundice within 10 days of starting loratadine [bilirubin rising to "low 20s", AST to "2,000 range"], with slowly progressive hepatic failure and ascites, ultimately undergoing liver transplant: possibly same as case 1 in Schiano [1996]). 8927291
Schiano TD, Bellary SV, Cassidy MJ, Thomas RM, Black M. Subfulminant liver failure and severe hepatotoxicity caused by loratadine use. Ann Intern Med 1996; 9: 738-40. (Two cases; 42 year old woman developed jaundice 12 months after starting loratadine leading to cholecystectomy and later liver transplant [bilirubin 10.3 mg/dL, ALT 609 U/L, Alk P 207 U/L], explant showing massive necrosis; 33 year old man developed jaundice 2 weeks after starting loratadine [bilirubin 16.0 mg/dL, ALT 1608 U/L, Alk P 132 U/L], resolving within 2 months). 8929007
Myers MW, Jick H. Terfenadine and risk of acute liver disease. Br J Clin Pharmacol 1998; 46: 251-3. (Population based survey of General Practice Research Database identified 3 cases of possible terfenadine induced jaundice among 210,683 recipients, but all 3 had other possible causes including use of other potentially hepatotoxic drugs). 9764966
Remy AJ, Debette M, Diaz D, Voigt JJ, Blanc P, Larrey D. [Dexchlorpheniramine-induced acute hepatitis: a case with positive rechallenge]. Gastroenterol Clin Biol 1998; 22: 831-2. French. (27 year old man developed jaundice 10 days after starting dexchlorpheniramine [bilirubin 13.7 mg/dL, ALT 50 times ULN, GGT 5 times ULN], resolving within 8 weeks of stopping and recurring within 10 days of restarting [bilirubin 9.4 mg/dL, ALT 40 times ULN, Alk P normal], despite tolerating cetirizine without problems). 9854210
Howarth PH, Stern MA, Roi L, Reynolds R, Bousquet J. Double-blind, placebo-controlled study comparing the efficacy and safety of fexofenadine hydrochloride (120 and 180 mg once daily) and cetirizine in seasonal allergic rhinitis. J Allergy Clin Immunol 1999; 104: 927-33. (In a controlled trial of fexofenadine vs cetirizine vs placebo in 822 patients with seasonal allergic rhinitis, rates of adverse events were similar but drowsiness was less with fexofenadine [3%] than cetirizine [6%]; no mention of hepatotoxicity). 10550734
Mason J, Reynolds R, Rao N. The systemic safety of fexofenadine HCl. Clin Exp Allergy 1999; 29 Suppl 3: 163-70. (In clinical trials of fexofenadine in a total of 2461 patients, adverse events were uncommon and similar to placebo, ALT elevations occurring in <1% of both groups; no mention of clinically apparent liver injury). 10444232
Mann RD, Pearce GL, Dunn N, Shakir S. Sedation with "non-sedating" antihistamines: four prescription-event monitoring studies in general practice. BMJ 2000; 320: 1184-6. (Postmarketing surveillance of side effects of four 2nd generation antihistamines found spontaneous reporting of drowsiness was higher for cetirizine [7.3%] than acrivastine [5.7%], loratadine [2.2%] and fexofenadine [2.8%], no mention of hepatotoxicity). 10784544
Philpot EE. Safety of second generation antihistamines. Allergy Asthma Proc 2000; 21: 15-20. (Review of safety of 2nd generation antihistamines focusing on sedation and impairment of motor performance, no mention of hepatotoxicity or ALT elevations). 10748947
Fong DG, Angulo P, Burgart LJ, Lindor KD. Cetirizine-induce cholestasis. J Clin Gastroenterol 2000; 31: 250-3. (28 year old man developed jaundice 2 years after starting cetirizine [bilirubin 9.7 mg/dL, ALT 215 U/L, Alk P 260 U/L], biopsy showing bland cholestasis; recovery was slow and incomplete). 11034010
Watanabe M, Kohge N, Kaji T. Severe hepatitis in a patient taking cetirizine. Ann Intern Med 2001; 135: 142-3. (23 year old man developed jaundice 9 months after starting cetirizine for atopic dermatitis [bilirubin 5.8 rising to 10.8 mg/dL, ALT 2476 U/L, Alk P "moderately elevated", protime 17.6 sec, eosinophils 13%], resolving within 44 days of stopping). 11453719
Sánchez-Lombraña JL, Alvarez RP, Sáez LR, Oliva NP, Martínez RM. Acute hepatitis associated with cetirizine intake. J Clin Gastroenterol 2002; 34: 493-5. (14 year old girl developed nausea and fatigue after 2nd and 3rd monthly 3 day course of cetirizine [bilirubin 1.3 mg/dL, ALT 1045 U/L, Alk P 291 U/L = normal, GGT 58 U/L, anti-LKM positive], resolving within 6 months of stopping). 11907376
Suyama T, Fujiwara H, Takenouchi K, Ito M. Drug eruption and liver injury caused by terfenadine and oxatomide. Eur J Dermatol 2002; 12: 385-6. (70 year old woman with psoriasis developed worsening skin lesions and jaundice while taking two antihistamines, terfenadine and oxatomide [bilirubin 8.0 mg/dL, ALT 255 U/L, Alk P 365 U/L], resolving on stopping both, but rash recurring with each individually and ALT with oxatomide). 12095890
Pompili M, Basso M, Grieco A, Vecchio FM, Gasbarrini G, Rapaccini GL. Recurrent acute hepatitis associated with use of cetirizine. Ann Pharmacother 2004; 38: 1844-7. (26 year old man developed jaundice within 1-2 weeks of starting cetirizine for allergic rhinitis [bilirubin 1.8 mg/dL, ALT 1606 U/L, Alk P normal, anti-LKM positive], resolving within 6 months, history compatible with 2 previous episodes after starting cetirizine). 15383643
Schöttker B, Dösch A, Kraemer DM. Severe hepatotoxicity after application of desloratadine and fluconazole. Acta Haematol 2003; 110: 43-4. (38 year old woman with T cell lymphoma developed enzyme elevations while on desloratadine [bilirubin 1.2 mg/dL, ALT 1264 U/L, Alk P 347 U/L, INR 2.3, LDH 6170 U/L], resolving within 10 days of stopping, but several other medications were also being given). 12975558
Kim H, Bindslev-Jensen C. Reported case of severe hepatotoxicity likely due to fluconazole and not desloratadine. Acta Haematol 2004; 112: 177-8. (Letter in response to Schöttker [2003] arguing that fluconazole was a more likely cause of the liver abnormalities). 15345904
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to antihistamines). 15390328
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one case was considered probably due to promethazine, but no other antihistamine was implicated). 18955056
Rodríguez-Gómez SJ, Zamora-Martínez T, Bailador-Andrés C, Fuentes-Coronel AM, Martín-Arribas MI. [Severe intrahepatic cholestasis associated with cetirizine]. Gastroenterol Hepatol 2009; 32: 383-4. (32 year old man developed jaundice and itching 4 months after starting cetirizine [bilirubin 28.7 mg/dL, ALT normal, Alk P 304 U/L], resolving within 3 months of stopping, biopsy showing bland cholestasis). 19457587
Segall N, Gawchik S, Georges G, Haeusler JM. Efficacy and safety of levocetirizine in improving symptoms and health-related quality of life in US adults with seasonal allergic rhinitis: a randomized, placebo-controlled study. Ann Allergy Asthma Immunol 2010; 104: 259-67. (Randomized trial of levocetirizine vs placebo for 14 days in 580 patients with seasonal allergic rhinitis found few adverse reactions; no mention of ALT elevations or hepatotoxicity). 20377116
Bachert C, Maurer M. Safety and efficacy of desloratadine in subjects with seasonal allergic rhinitis or chronic urticaria: results of four postmarketing surveillance studies. Clin Drug Investig 2010; 30: 109-22. (In postmarketing surveillance studies, spontaneous adverse event reports were received from 287 of 77,880 patients [0.4%] receiving desloratadine for an average of 40 days; no mention of hepatic side effects). 20067329
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury but none were attributed to antihistamines). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic and most common agents were isotretinoin, acetaminophen, valproic acid, carbamazepine, methotrexate, minocycline, lamotrigine, zidovudine, pemoline and ceftriaxone; no antihistamines were listed). 21039766
Díaz-Sánchez A, Marín-Jiménez I, Aldeguer M. [Benign recurrent intrahepatic cholestasis simulating cetirizine-induced toxic hepatitis]. Gastroenterol Hepatol 2010; 33: 68-9. Spanish. (22 year old man developed jaundice while on long term cetirizine [bilirubin 13.7 mg/dL, ALT 92 U/L, GGT 56 U/L], resolving in one month and recurring twice while not taking cetirizine, and therefore believed to be due to benign recurrent intrahepatic cholestasis [BRIC] rather than cetirizine hepatotoxicity). 19729225
Jurawan R, Smith A. Severe hepatitis in a primary sclerosing cholangitis patient receiving recent cetirizine therapy. N Z Med J 2010; 123: 106-7. (66 year old man with sclerosing cholangitis developed elevated liver tests 1 month after starting cetirizine [bilirubin 1.7 mg/dL, ALT 1577 U/L, Alk P 264 U/L, GGT 347 U/L], returning to baseline values upon stopping). 20186247
Prieto de Paula JM, Franco Hidalgo S, Nalotto L, Ginés Santiago A. [Cetirizine hepatotoxicity]. Med Clin (Barc) 2011; 137: 283-4. Spanish. (39 year old woman developed jaundice and itching 8 weeks after starting cetirizine [bilirubin 6.9 mg/dL, ALT 77 U/L, Alk P 238 U/L], resolving within 3 months of stopping). 21145082
Compalati E, Baena-Cagnani R, Penagos M, Badellino H, Braido F, Gómez RM, Canonica GW, Baena-Cagnani CE. Systematic review on the efficacy of fexofenadine in seasonal allergic rhinitis: a meta-analysis of randomized, double-blind, placebo-controlled clinical trials. Int Arch Allergy Immunol 2011; 156: 1-15. (Systematic review of efficacy and safety of fexofenadine from 8 controlled trials including 3532 patients found no differences in rates of adverse events between fexofenadine and placebo; no mention of ALT results or hepatotoxicity). 21969990
Ferrer M. Pharmacokinetic evaluation of levocetirizine. Expert Opin Drug Metab Toxicol 2011; 7: 1035-47. (Review of pharmacology, safety and efficacy of levocetirizine, the levorotatory enantiomer of cetirizine; no discussion of hepatotoxicity). 21639816
Ekiz F, Yüksel I, Ekiz O, Coban S, Basar O, Yüksel O. Levocetirizine induced hepatotoxicity in a patient with chronic urticaria. Ann Hepatol 2011; 10: 237-8. (64 year old man developed abnormal liver tests 2 weeks after starting levocetirizine for urticaria [bilirubin normal, ALT 115 U/L, Alk P 440 U/L], resolving within 3 weeks of stopping). 21502689
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which none were attributed to an antihistamine). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to an antihistamine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was considered probably related to promethazine, but no other antihistamine was implicated). 25754159
Serper M, Wolf MS, Parikh NA, Tillman H, Lee WM, Ganger DR. Risk factors, clinical presentation, and outcomes in overdose with acetaminophen alone or with combination products: results from the Acute Liver Failure Study Group. J Clin Gastroenterol 2016; 50: 85-91. (Among 666 cases of acetaminophen [APAP] induced acute liver failure enrolled in a prospective database between 1996 and 2012, 87 [14%] ingested a combination of dihenhydramine and APAP while 202 [30%] ingested APAP alone; there were no differences in severity of the injury, speed of recovery or clinical outcomes between the two groups). 26166142